# Tildrakizumab

## OVERVIEW

### Introduction

Tildrakizumab is humanized monoclonal antibody to interleukin-23 that is used to treat moderate-to-severe plaque psoriasis. Tildrakizumab is associated with a low rate of transient and asymptomatic serum enzyme elevations during therapy, but has not been linked to cases of idiosyncratic, clinically apparent liver injury.

### Background

Tildrakizumab (til" dra kiz' ue mab) is a humanized monoclonal IgG1 antibody to interleukin (IL)-23, a cytokine that is an important mediator of autoimmune reactions. IL-23 is found in the skin lesions of psoriasis and in the affected gastrointestinal mucosa of patients with inflammatory bowel disease. Among the monoclonal IL-23 inhibitors, tildrakizumab and guselkumab are directed to the p19 subunit of IL-23, whereas ustekinumab is directed at the p40 subunit which is a component shared by both IL-23 and IL-12. As a consequence, tildrakizumab and guselkumab have a more restricted activity in the Th17 immune pathways which are considered to play a major role in autoimmune reactions. Tildrakizumab has been shown to improve symptoms and signs of plaque psoriasis and was approved for this use in United States in 2017. While current indications are limited to moderate-to-severe plaque psoriasis, tildrakizumab is under active investigation as therapy of several other autoimmune diseases. Tildrakizumab is available in liquid solution in single use prefilled syringes of 100 mg/mL under the brand name Ilumya. The typical regimen is 100 mg subcutaneously initially, 4 weeks later and every 8 weeks thereafter. Side effects are uncommon and are usually mild, but may include injection site reactions, headache, diarrhea and minor infections such as upper respiratory infections. Less common, but potentially severe side effects include serious infections, hypersensitivity reactions and reactivation of tuberculosis.

### Hepatotoxicity

Rates of serum aminotransferase elevations during tildrakizumab therapy have not been well defined, but rates of laboratory result abnormalities are said to be similar with tildrakizumab compared to placebo treatment. Neither during premarketing evaluation nor subsequently have there been case reports of clinically apparent, acute liver injury with symptoms or jaundice linked to tildrakizumab therapy, but experience with its use has been limited.

Tildrakizumab has immunosuppressive activity but has not been linked to instances of reactivation of hepatitis B or worsening of hepatitis C. However, patients at risk for these complications are often excluded from preregistration clinical trials, and ustekinumab, a similar biologic agent which is also active against IL-23 and is used to treat psoriasis, has been shown to cause reactivation of hepatitis B in postmarketing studies. HBV reactivation typically occurs in patients with preexisting HBsAg and relatively inactive disease. Reactivation causes acute hepatocellular injury that can be severe and lead to acute liver failure and death or need for emergency liver transplantation. Screening for hepatitis B before starting tildrakizumab is not recommended in the product label, but screening has been considered “advisable” in guidelines written by academic societies for many monoclonal antibodies used for psoriasis.

Likelihood score: E* (unlikely cause of clinically apparent liver injury but experience with its use has been limited).

### Mechanism of Liver Injury

The mechanism of possible liver injury due to tildrakizumab is not known. Reactivation of hepatitis B appears to be due to a brisk immunological response to newly expressed viral antigens caused by suppression of the immune response to hepatitis B antigens. Injury generally arises between courses of immunosuppressive therapy.

### Outcome and Management

Tildrakizumab has been linked to minor elevations in serum enzymes during therapy but not to clinically apparent liver injury or with reactivation of hepatitis B. The product label for tildrakizumab does not recommend routine screening for hepatitis B before initiation of therapy. However, guidelines prepared by some academic societies on the management of patients who are to receive biological agents similar to tildrakizumab have recommended routine screening before starting treatment. Screening should include tests for HBsAg and anti-HBc (and perhaps also anti-HBs as this may help in management). Prophylaxis with a potent oral, antiviral agent effective against hepatitis B is recommended for persons who have HBsAg in serum. An alternative approach is careful monitoring for HBV DNA during therapy and early institution of antiviral therapy if levels rise.

Drug Class: Dermatologic Agents, Psoriasis Agents; Monoclonal Antibodies

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Tildrakizumab – Ilumya®

DRUG CLASS

Dermatologic Agents, Psoriasis Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Tildrakizumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Tildrakizumab | 1326244-10-3 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 20 October 2018

Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of immunosuppressive agents; does not mention tildrakizumab specifically, but discusses the problems of reactivation of hepatitis B and states that "the biological immunosuppressants are largely free from hepatotoxicity, with the exception of the TNF alpha antagonists").
Chabner BA, Barnes J, Neal J, Olson E, Mujagiv H, Sequist L, Wilson W, et al. Targeted therapies: tyrosine kinase inhibitors, monoclonal antibodies, and cytokines. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1731-53. (Textbook of pharmacology and therapeutics).
https://www.accessdata.fda.gov/scripts/cder/daf/ (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy which mentions that there were no clinically meaningful changes in laboratory test results in the phase 1, 2 or 3 studies of tildrakizumab).
Leonardi CL, Kimball AB, Papp KA, Yeilding N, Guzzo C, Wang Y, Li S, et al.; PHOENIX 1 study investigators. Efficacy and safety of ustekinumab, a human interleukin-12/23 monoclonal antibody, in patients with psoriasis: 76-week results from a randomised, double-blind, placebo-controlled trial (PHOENIX 1). Lancet 2008; 371 (9625): 1665-74. (Among 766 patients with psoriasis treated with 1 of 2 doses of ustekinumab or placebo for 12 weeks, response rates were 67% and 66% with ustekinumab vs 3% with placebo, and side effects were similar and "results of laboratory results were much the same" in the 3 groups). 18486739
Motaparthi K, Stanisic V, Van Voorhees AS, Lebwohl MG, Hsu S; Medical Board of the National Psoriasis Foundation. From the Medical Board of the National Psoriasis Foundation: Recommendations for screening for hepatitis B infection prior to initiating anti-tumor necrosis factor-alfa inhibitors or other immunosuppressive agents in patients with psoriasis. J Am Acad Dermatol 2014; 70: 178-86. (Mentions that little is known about the effects of ustekinumab on HBV infection, but that screening for hepatitis B markers is "advisable" before its use). 24220724
Papp K, Thaçi D, Reich K, Riedl E, Langley RG, Krueger JG, Gottlieb AB, et al. Tildrakizumab (MK-3222), an anti-interleukin-23p19 monoclonal antibody, improves psoriasis in a phase IIb randomized placebo-controlled trial. Br J Dermatol 2015; 173: 930-9. (Among 355 patients with plaque psoriasis treated with tildrakizumab [5, 25, 100 or 200 mg] or placebo for 52 weeks, clinical improvement response rates were 33-74% vs 4% with placebo and overall and serious adverse reactions were similar in all arms and there were no liver related serious adverse events; no mention of ALT elevations or hepatotoxicity). 26042589
Reich K, Papp KA, Blauvelt A, Tyring SK, Sinclair R, Thaçi D, Nograles K, et al. Tildrakizumab versus placebo or etanercept for chronic plaque psoriasis (reSURFACE 1 and reSURFACE 2): results from two randomised controlled, phase 3 trials. Lancet 2017; 390: 276-88. (Among 1862 patients with plaque psoriasis enrolled in two 12-week controlled trials, clinical response rates were higher with tildrakizumab [61-66%] than placebo [6-7%] and etanercept [48%], while adverse event rates were similar in all groups; no mention of ALT elevations or hepatotoxicity). 28596043
Blauvelt A, Reich K, Papp KA, Kimball AB, Gooderham M, Tyring SK, Sinclair R, et al. Safety of tildrakizumab for moderate-to-severe plaque psoriasis: pooled analysis of three randomized controlled trials. Br J Dermatol 2018; 179: 615-22. (Among 2081 patients with moderate-to-severe plaque psoriasis enrolled in 3 placebo-controlled trials, serious adverse event rates, discontinuations due to side effects, major cardiovascular events, and severe infections occurred at similar rates in both groups; no mention of ALT elevations or hepatotoxicity). 29742274
Markham A. Tildrakizumab: first global approval. Drugs 2018; 78: 845-9. (Review of the mechanism of action, history of development, pharmacology, clinical efficacy and safety of tildrakizumab). 29752706

## OTHER REFERENCE LINKS

1. Recent References on Tildrakizumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Tildrakizumab/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Tildrakizumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Tildrakizumab)